# Pralsetinib

## OVERVIEW

### Introduction

Pralsetinib is an oral selective inhibitor of the tyrosine kinase receptor encoded by RET (rearranged during transfection), a proto-oncogene which is mutated or altered in many cancers such a medullary thyroid cancer and non-small cell lung cancer. Serum aminotransferase elevations are common during pralsetinib therapy and can lead to dose modifications or discontinuations, but pralsetinib has not been linked to clinically apparent liver injury with jaundice.

### Background

Pralsetinib (pral seh’ ti nib) is an orally available, small molecule inhibitor of the tyrosine kinase receptor encoded by the proto-oncogene RET (rearranged during transfection), which is mutated or altered in several cancers including 1% to 2% of non-small cell lung cancer (NSCLC), up to 70% of medullary thyroid cancers and approximately 10% of other thyroid cancers. Pralsetinib was found to be a potent inhibitor of cell growth and proliferation in tumor cell lines and experimental tumor models with RET mutations or RET gene fusion. In open label trials of pralsetinib in patients with advanced or metastatic medullary thyroid cancer and NSCLC harboring alterations in RET, objective response rates ranged from 56% to 85%. Pralsetinib was given accelerated approval for use in the United States in 2020 and subsequently received full approval. It has shown efficacy in several other solid tumors that harbor RET gene-alterations. Pralsetinib is available in capsules of 100 mg under the brand name Gavreto. The recommended dose is 400 mg once daily in adults and children 12 years of age or above. Side effects are common and can include dry mouth, diarrhea, constipation, abdominal pain, nausea, systemic arterial hypertension, myalgia, fever, cough, edema, anemia, neutropenia, elevations in serum creatinine, uric acid, and aminotransferase levels. Uncommon but potentially severe adverse events include interstitial pneumonitis, severe hypertension, hemorrhagic events, tumor lysis syndrome, impaired wound healing, and embryo-fetal toxicity. In preregistration trials, adverse events led to dose interruptions in 60%, dose reductions in 36%, and permanent discontinuations in 15% of pralsetinib treated patients. Deaths from treatment related adverse events were rare [<1%] and usually due to sepsis or pneumonitis.

### Hepatotoxicity

In the prelicensure clinical trials of pralsetinib in patients with RET mutations or RET fusion gene-positive solid tumors, liver test abnormalities were frequent although usually mild. Some degree of ALT elevation arose in 41% of pralsetinib treated patients, but were above 5 times the upper limit of normal (ULN) in only 2% to 3%. The median time to onset of ALT elevations was 22 days with a range of 7 days to more than a year. In these trials that enrolled approximately 438 patients, serious hepatic adverse events were reported in 2.1% but were mostly transient serum aminotransferase elevations. There were no fatal hepatic events and no instance of clinically apparent liver injury with jaundice. Pralsetinib was discontinued early due to increased AST or ALT in 0.8% of patients. Thus, in preregistration trials of pralsetinib there were no instances of clinically apparent liver injury with jaundice, but therapy was associated with a high rate of serum ALT elevations and the total clinical experience with its use has been limited. Nevertheless, careful monitoring of liver tests is recommended during pralsetinib therapy.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the serum aminotransferase elevations during pralsetinib therapy is unknown, but the pattern of abnormalities and the response to dose adjustment suggests some degree of low level, direct hepatotoxicity. Pralsetinib is metabolized in the liver via the cytochrome P450 system, largely CYP 3A4, and is susceptible to drug-drug interactions with agents that inhibit or induce the CYP enzyme reactivity.

### Outcome and Management

The product label for pralsetinib recommends monitoring for routine liver tests before, at 2-week intervals during the first 3 months of therapy, and monthly thereafter as clinically indicated. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary cessation of pralsetinib therapy until serum enzymes return to normal or near normal levels. In patients with clinically apparent liver injury and jaundice, restarting therapy should be done with caution. Cross sensitivity to liver injury is uncommon among the tyrosine kinase inhibitors, but there is no information or shared adverse event sensitivity of pralsetinib with other RET inhibitors such as selpercatinib or other antineoplastic protein kinase inhibitors.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Related Drugs: Selpercatinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pralsetinib – Gavreto®

DRUG CLASS

Antineoplastic Agents, Kinase Inhibitors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Pralsetinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Pralsetinib | 2097132-94-8 | C27-H32-F-N9-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 12 August 2023

Abbreviations: NSCLC, non-small cell lung cancer; RET, rearranged in transfection.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of protein kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents, does not discuss pralsetinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/213721Orig1s000MultidisciplineR.pdf (FDA website with product labels and initial multidiscipline review of the safety and efficacy of pralsetinib; states that virtually all patients treated [n=438] had at least one adverse event, but there were only 7 serious hepatic adverse events that were mostly ALT or AST elevations and no patient developed clinically apparent liver injury with jaundice; in the 220 patients with NSCLC treated with pralsetinib, 46% had an ALT elevations but only 2.1% were above 5 times ULN).
Markham A. Pralsetinib: first approval. Drugs. 2020;80:1865-1870. (Review of the mechanism of action, chemical structure, history of development, pharmacology, clinical efficacy and safety of pralsetinib mentions that AST and ALT elevations were the most common treatment related adverse events, increased ALT elevations accounting for some dosage interruptions but not discontinuations). 33136236
Kim J, Bradford D, Larkins E, Pai-Scherf LH, Chatterjee S, Mishra-Kalyani PS, Wearne E, et al. FDA Approval Summary: Pralsetinib for the treatment of lung and thyroid cancers with RET gene mutations or fusions. Clin Cancer Res. 2021;27:5452-5456. (Summary of the data on efficacy and safety of pralsetinib [n=438 patients] that led to its accelerated approval by the FDA mentions that serious hepatic adverse events arose in 2% of patients with ALT or AST elevations above 5 times ULN in 6% and 5%, but that there were no cases of clinically apparent liver injury with jaundice or hepatic related deaths). 34045295
Subbiah V, Hu MI, Wirth LJ, Schuler M, Mansfield AS, Curigliano G, Brose MS, et al. Pralsetinib for patients with advanced or metastatic RET-altered thyroid cancer (ARROW): a multi-cohort, open-label, registrational, phase 1/2 study. Lancet Diabetes Endocrinol. 2021;9:491-501. (Among 122 patients with RET-mutated medullary and 20 with RET-fusion-positive thyroid cancer treated with pralsetinib for a median of 12 months, the overall response rates were 60-71%, while adverse events arose in 97% including ALT elevations in 23% that were above 5 times ULN in 2 patients, but there were no discontinuations for ALT or AST elevations and no liver related deaths). 34118198
Gainor JF, Curigliano G, Kim DW, Lee DH, Besse B, Baik CS, Doebele RC, et al. Pralsetinib for RET fusion-positive non-small-cell lung cancer (ARROW): a multi-cohort, open-label, phase 1/2 study. Lancet Oncol. 2021;22:959-969. (Among 233 patients with RET fusion-positive NSCLC treated with pralsetinib [400 mg daily], overall responses occurred in 61% of previously treated and 70% of treatment-naïve subjects, while virtually all patients had at least one adverse events including ALT elevations in 27% which were above 5 times ULN in 5 patients [3%], but there were no treatment related deaths). 34118197
Passaro A, Russo GL, Passiglia F, D'Arcangelo M, Sbrana A, Russano M, Bonanno L, et al. Pralsetinib in RET fusion-positive non-small-cell lung cancer: A real-world data (RWD) analysis from the Italian expanded access program (EAP). Lung Cancer. 2022;174:118-124. (Among 62 patients with RET-fusion positive NSCLC treated with pralsetinib for a median of 10 months in 20 Italian centers in an expanded access program, the objective response rate was 66% and adverse events were frequent including ALT or AST elevations above 5 times ULN in 5%, but there were no hepatic related deaths). 36379124
Griesinger F, Curigliano G, Thomas M, Subbiah V, Baik CS, Tan DSW, Lee DH, et al. Safety and efficacy of pralsetinib in RET fusion-positive non-small-cell lung cancer including as first-line therapy: update from the ARROW trial. Ann Oncol. 2022;33:1168-1178. (Among 281 with RET fusion-positive NSCLC treated with pralsetinib in the ARROW trial [Gainor 2021], further follow up identified tumor shrinkage in all treatment-naïve and in 97% of previously treated subjects, while adverse events recorded for a total of 528 patients with cancer treated with pralsetinib, included ALT elevations in 29% which were above 5 times ULN in 2%). 35973665
Subbiah V, Cassier PA, Siena S, Garralda E, Paz-Ares L, Garrido P, Nadal E, et al. Pan-cancer efficacy of pralsetinib in patients with RET fusion-positive solid tumors from the phase 1/2 ARROW trial. Nat Med. 2022;28:1640-1645. (Among 29 patients with 12 different RET fusion-positive solid tumor types [excluding NSCLC and thyroid cancer] treated with pralsetinib, the overall response rate was 57% and all patients had at least one adverse event including ALT elevations in 10 patients [34%], which were above 5 times ULN in 2 patients [7%] who required dose interruption but not permanent discontinuation). 35962206
Two drugs for RET-altered cancers (Retevmo and Gavreto). Med Lett Drugs Ther. 2023;65:e129-e131. (Concise review of the mechanism of action, clinical efficacy, safety and costs of selpercatinib and pralsetinib, two kinase inhibitors that act on RET gene altered cancers mentions that liver enzyme elevations are frequent and monitoring of ALT and AST levels is recommended).

## OTHER REFERENCE LINKS

Recent References on Pralsetinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Pralsetinib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Pralsetinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pralsetinib)